# Valproate

## OVERVIEW

### Introduction

Valproate or valproic acid is a branched chain organic acid that is used as therapy of epilepsy, bipolar disorders and migraine headaches and is a well known cause of several distinctive forms of acute and chronic liver injury.

### Background

Valproate (val proe' ate) is a carboxylic acid derivative that appears to act by increasing brain levels of gamma aminobutyric acid (GABA), the major inhibitory neurotransmitter in the human brain. Valproate has been shown to be effective in several forms of seizures. Valproate was approved for therapy of epilepsy in adults and children in 1978 and is currently one of the major anticonvulsant medications used. Current approved uses include both monotherapy and in combination with other anticonvulsants for complex absence seizures, complex partial seizures and mixed seizure types. Valproate is also used for prevention of migraine headaches and for bipolar disorders. The recommended dose of valproate varies by indication. The initial recommended dose for therapy of seizures is 10 to 15 mg/kg/day, with increases of 5 to 10 mg/kg/day weekly to achieve an optimal clinical response. Monitoring of drug levels is often recommended. Valproate is available in multiple generic and brand formulations as capsules, tablets and syrups and in delayed release forms of 125, 250 and 500 mg. Oral forms also include divalproex, which dissociates into valproate in the gastrointestinal tract and is available in capsules of 125 mg under the brand name Depakote. Valproate sodium is also available in parenteral formulations. Valproate has multiple side effects and clinically significant drug interactions; common side effects include headache, insomnia, nervousness, somnolence, tremor, blurred vision, nausea, weight gain and rash. Uncommon but potentially severe adverse reactions include pancreatitis, hepatotoxicity, embryo-fetal toxicity, birth defects, suicidal ideation and behaviors, thrombocytopenia, hyperthermia, hyperammonemia and severe drug-drug interactions.

### Hepatotoxicity

Prospective studies suggest that 5% to 10% of persons develop ALT elevations during long term valproate therapy, but these abnormalities are usually asymptomatic and can resolve even with continuation of drug. Unlike phenytoin and carbamazepine, valproate does not induce elevations in serum GGT levels. More importantly and not uncommonly, valproate can cause several forms of clinically apparent hepatotoxicity. Indeed, more than 100 fatal cases of acute or chronic liver injury due to valproate have been reported in the literature. Three clinically distinguishable forms of hepatotoxicity (besides simple aminotransferase elevations) can occur with valproate.

The first syndrome is hyperammonemia with minimal or no evidence of hepatic injury. This syndrome typically presents with progressive and episodic confusion followed by obtundation and coma. The time to onset is often within a few weeks of starting valproate or increasing the dose, but it can present months or even years after starting the medication (Case 1). The diagnosis is made by the finding of elevations in serum ammonia with normal (or near normal) serum aminotransferase and bilirubin levels. Valproate levels are usually normal or minimally high. The syndrome resolves within a few days of stopping valproate, but may reverse more rapidly with carnitine supplementation or renal hemodialysis.

The second form of injury from valproate is an acute hepatocellular injury with jaundice, typically accompanied by hepatocellular or mixed pattern of enzyme elevations (Case 2). This acute liver injury pattern usually has its onset within 1 to 6 months of starting valproate. The pattern of serum enzyme elevations can be hepatocellular or mixed; sometimes the serum aminotransferase levels are not markedly elevated, despite the severity of injury.

Immunoallergic features (fever, rash, eosinophilia) are usually absent, but rare cases with prominent features of hypersensitivity have been reported (Case 3). Multiple instances of fatal acute hepatic failure due to valproate have been published and valproate is regularly listed as a cause of drug induced acute liver failure. Liver histology is distinctive and reveals a microvesicular steatosis with central lobular necrosis, mild to moderate inflammation and cholestasis. In cases with a prolonged course, fibrosis, bile duct proliferation and regenerative nodules may be present. Prospective studies using historical controls suggest that carnitine (particularly intravenously) may be beneficial if given soon after presentation.

The third form of hepatic injury due to valproate is a Reye-like syndrome described in children on valproate who develop fever and lethargy (suggestive of a viral infection) followed by confusion, stupor and coma, with raised ammonia levels and marked ALT elevations but normal or minimally elevated bilirubin levels. Metabolic acidosis is also common and the syndrome can be rapidly fatal. Valproate may simply be an aspirin-like agent capable of triggering Reye syndrome if it is being taken when the child develops either influenza or varicella infection.

All three forms of valproate hepatotoxicity have features of mitochondrial injury, and liver histology usually demonstrates microvesicular steatosis with variable amounts of inflammation and cholestasis. Young age (<2 years), presence of other neurological conditions and concurrent use of other anticonvulsants appear to be important risk factors for acute liver failure due to valproate. Valproate has been rarely associated with anticonvulsant hypersensitivity syndrome and generally is a safe alternative in patients with that syndrome caused by the aromatic anticonvulsants.

Likelihood score: A (well known cause of several forms of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of valproate hepatotoxicity is thought to be due to mitochondrial toxicity, perhaps from inhibition of beta oxidation and subsequent loss of mitochondrial function. Valproate is extensively metabolized by the liver and excreted in urine. Valproate therapy lowers tissue carnitine levels which may affect mitochondrial function and cause the hyperammonemia and microvesicular steatosis. Genetic factors also appear to be important, as valproate hepatotoxicity is more common in patients who are heterozygous for mutations in gamma polymerase, the predominant DNA polymerase found in mitochondria. Children with the Alpers-Huttenlocher syndrome who are homozygous for this mutation are at very high risk of developing valproate hepatotoxicity which is often fatal and responds poorly to liver transplantation. Alpers syndrome is characterized by progressive cerebral degeneration, seizures and cirrhosis and has been shown to be due to mutations in the gene for polymerase gamma, the enzyme responsible for mitochondrial DNA replication. Indeed, valproate is considered contraindicated in children with known or suspected Alpers-Huttenlocher syndrome.

### Outcome and Management

Valproate hepatotoxicity varies in severity from minimal and asymptomatic ALT elevations to severe liver injury with progressive jaundice, hepatic synthetic dysfunction, coma and death. Monitoring of symptoms and serum aminotransferase levels is recommended for children for the first 6 months of valproate therapy. Valproate has not been associated with vanishing bile duct syndrome, but cases of cirrhosis with severe fibrosis have been attributed to chronic indolent hepatotoxicity from valproate. Importantly, carnitine appears to be a specific antidote for valproate hepatotoxicity and studies in animal models and human studies with historical controls suggest that prompt administration of carnitine (particularly when given intravenously) improves survival in acute valproate hepatotoxicity. Oral carnitine was approved for use in valproate toxicity in 1992 and an intravenous formulation in 1996. The typically recommended dose is 100 mg/kg intravenously over 30 minutes (but less than 6 grams), followed by 15 mg/kg every four hours until clinical improvement.

Drug Class: Anticonvulsants

## CASE REPORTS

### Case 1. Hyperammonemia due to valproate.(1)

A 47 year old woman with left frontal astrocytoma was admitted to the hospital for a syncopal episode and control of seizures. She was being treated with phenobarbital, valproate and levetiracetam. While hospitalized she was started on irradiation for her brain tumor. After a month in the hospital, her seizures were reasonably well controlled, but she developed unexplained somnolence and confusion. Liver tests were not abnormal, but serum ammonia levels were markedly elevated. Valproate was stopped and her mental status improved rapidly, ammonia levels decreasing into the normal range within 3 days. She subsequently improved and was discharged two weeks later.

#### Key Points

Medication: | Valproate (450 mg/day)
Pattern: | (R=not applicable)
Severity: | 1+ (no jaundice)
Latency: | 3 months
Recovery: | 4 days
Other medications: | Phenobarbital, levetiracetam, phenergan (all were continued)

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Ammonia (µmol/L) | Comments
0 | | Valproate started: 500 mg daily
60 days | | 15 | 50 | 0.4 | | Hospital admission
80 days | | 15 | 58 | 0.2
90 days | 0 | 28 | 59 | 0.1 | 286
91 days | 1 days | | | | 362 | Valproate stopped
92 days | 2 days | | | | 70
93 days | 3 days | | | | 36
96 days | 6 days | 74 | 74 | 0.1 | 20
103 days | 13 days | 90 | 155 | 0.3 | 37
Normal Values | | <42 | <115 | <1.2

#### Comment

A woman on multiple anticonvulsants developed somnolence and confusion during a prolonged hospitalization during which she was receiving radiation for a brain astrocytoma. While there were other possible reasons for her change in mental status, astute physicians tested her blood ammonia level, which was markedly elevated. Withdrawal of valproate led to a prompt improvement. This case represents the hyperammonemia of valproate that typically occurs without other evidence of hepatitis injury, although hyperammonemia is believed to be caused by the effects of valproate on hepatic mitochondrial function.

### Case 2. Acute liver failure due to valproate.(1)

A 15 year old adolescent male with seizures being treated with valproate was admitted to the hospital having developed jaundice after a three week history of fatigue and body aches. He had developed seizures at age 9 and was treated with phenytoin for several years, but was switched to valproate (750 mg/day) because of reappearance of seizures approximately 4 months before admission. Three weeks before admission, he developed an influenza-like illness with fever, fatigue, body aches and diarrhea. The diarrhea resolved, but fatigue persisted. He was seen for evaluation and found to have elevations in liver tests. He was treated with azithromycin, but continued to do poorly developing behavioral changes and then jaundice. Valproate was stopped, and he was admitted to the hospital 4 days later because of worsening jaundice and confusion. On examination, he was disoriented and jaundiced but without signs of chronic liver disease, rash or fever. Serum bilirubin was 11.5 and INR 4.1 (Table). He was placed in intensive care. Tests for hepatitis A, B and C and autoantibody tests were negative, and serum ceruloplasmin and copper were normal. An abdominal ultrasound showed no evidence of biliary obstruction. His hepatic failure worsened and he was transferred to a liver transplant center, undergoing liver transplantation ~3 weeks after his initial admission.

#### Key Points

Medication: | Valproate (250→750 mg/day)
Pattern: | Mixed (R=4.3)
Severity: | 5+ (acute liver failure requiring liver transplantation)
Latency: | 3 months
Recovery: | No
Other medications: | Azithromycin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | | Comments
0 | | Valproate started: 250 mg raised to 750 mg daily
3.5 months | -3 weeks | 287 | 441 | | 1.4 | Given azithromycin
| 0 | 248 | 423 | | 3.1
4 months | 5 days | 240 | 401 | | 15.2 | Admission: INR 4.1
| 8 days | 147 | 267 | | 15.5
| 15 days | 89 | 161 | | 23.8
5 months | 22 days | 51 | 237 | | 26.7 | Liver transplantation
Normal Values | | <42 | <115 | | <1.2

#### Comment

Acute liver failure due to valproate hepatotoxicity. The latency period of 3 months and only moderate elevation in serum aminotransferase levels are typical of the acute hepatotoxicity from valproate. The explant showed massive hepatic necrosis with regenerative areas and mild fibrosis. The incubation period to onset of valproate hepatotoxicity is usually 1 to 3 months. Symptoms developing during this period should lead to a prompt discontinuation of valproate and administration of carnitine. In this instance, the history of a viral-like illness immediately before the onset of liver injury suggests a Reye-like syndrome. However, the clinical course and outcome were more typical of the acute hepatitis-like syndrome caused by valproate.

### Case 3. Drug rash with eosinophilia and acute liver failure due to valproate.(2)

A 26 year old man developed fever, rash and lymphadenopathy 1.5 months after starting valproic acid (500 mg twice daily) because of seizures arising after an intracerebral bleed. He had no history of liver disease, alcohol abuse, drug allergies or risk factors for viral hepatitis. His other medications included baclofen (500 mg three times daily), clemastine (2 mg twice daily) and acetaminophen (1 gram four times daily). Upon presentation, physical examination revealed a generalized papular-pustular rash, facial edema, lymphadenopathy and scleral icterus. Laboratory testing showed a total serum bilirubin of 10.5 mg/dL (direct 6.7 mg/dL), ALT 2800 U/L, AST 1219 U/L, alkaline phosphatase 456 U/L, GGT 216 U/L and prothrombin time 21.6 seconds. Acetaminophen levels were undetectable and valproate levels were "subtherapeutic". Tests for viral hepatitis and autoimmune conditions were unrevealing. Abdominal ultrasound demonstrated enlargement of the liver and spleen but no evidence of biliary obstruction. A skin biopsy was compatible with a drug-induced hypersensitivity rash. Valproate and acetaminophen were stopped upon admission and the seizure disorder was managed with levetiracetam. Prednisone was started and the skin rash, lymphadenopathy and facial edema resolved rapidly. Symptoms resolved within 6 weeks and laboratory tests returned to normal by 15 weeks, at which point prednisolone was stopped.

#### Key Points

Medication: | Valproic acid (500 mg, twice daily)
Pattern: | Hepatocellular (R=17)
Severity: | 4+ (jaundice and prolonged prothrombin time)
Latency: | 1.5 months
Recovery: | 15 weeks
Other medications: | Acetaminophen, baclofen, clemastine

#### Comment

A man with recent onset of seizures developed the syndrome of drug-rash with eosinophilia and systemic symptoms (DRESS) within 6 weeks of starting valproic acid. He had fairly severe liver injury with jaundice and prolongation of the prothrombin time, but without other evidence of hepatic failure (encephalopathy or ascites). He responded rapidly upon discontinuation of the valproate and institution of prednisolone. DRESS syndrome is well known to occur with aromatic anticonvulsant therapy (phenytoin, phenobarbital, carbamazepine, lamotrigine), but is rare with valproate therapy alone. DRESS and Stevens-Johnson syndrome have also been linked to acetaminophen therapy, but quite rarely. In this instance, acetaminophen may have contributed to the severity of liver injury but was probably not primarily responsible. While this case report lacked some necessary information (eosinophil count, hepatitis virus serology, autoimmune marker testing), it is fairly convincing and demonstrates the wide variability in clinical presentation of valproate induced liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Valproate – Generic, Depakene®, Depakote®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Valproate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Valproate | 99-66-1 | C8-H16-O2

## CITED REFERENCES

1 Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology.
2 van Zoelen MA, de Graaf M, van Dijk MR, Bogte A, van Erpecum KJ, Rockmann H, Maarschalk-Ellerbroek LJ. (2012). Valproic acid-induced DRESS syndrome with acute liver failure. Neth J Med.

## ANNOTATED BIBLIOGRAPHY

Selected References updated: 31 July 2020

Abbreviations used: DRESS, drug rash with eosinophilia and systemic symptoms; SJS/TEN, Stevens-Johnson syndrome and toxic epidermal necrolysis.

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of valproate and liver injury published in 1999, estimated to occur in ~1:5,000 patients, more frequent in infants <2 years, onset insidious after 1-4 months of treatment [range 3 days-2 years], typically with ALT 3-25 times ULN, and with microvesicular steatosis and centrolobular necrosis on biopsy; high fatality rate).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-41. (Review of anticonvulsant induced liver injury mentions that the onset of liver injury from valproate is typically after 1 to 3 months, but is variable and instances of onset within days and after years of use have been published).
Smith MD, Metcalf CS, Wilcox KS. Pharmacology of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
Huttenlocher PR, Solitare GB, Adams G. (1976). Infantile diffuse cerebral degeneration with hepatic cirrhosis. Arch Neurol. (Description of 4 children [2 pair of siblings] who developed developmental delay and seizures starting between 1 and 3 years of age and progressing to disability and death in infancy, often with evidence of steatosis and cirrhosis, which is now often called Alpers-Huttenlocher syndrome [AHS]).
Sackellares JC, Lee SI, Dreifuss FE. (1979). Stupor following administration of valproic acid to patients receiving other antiepileptic drugs. Epilepsia. (4 cases of stupor due to valproate; 2 men and 2 women, ages 8 to 37 years, with onset 2-30 days after valproate added to other anticonvulsants, resolving in 3-7 days after stopping; normal valproate levels, ammonia levels not tested).
Suchy FJ, Balistreri WF, Buchino JJ, Sondheimer JM, Bates SR, Kearns GL, Stull JD, Bove KE. (1979). Acute hepatic failure associated with the use of sodium valproate. Report of two fatal cases. N Engl J Med. (Two fatal cases of valproate induced liver injury arising 6 and 8 weeks after starting valproate in 5 and 11 year olds [bilirubin 7.0 rising to 31 and 2.6 to 22 mg/dL, ALT 58 and 280 U/L, Alk P 15.7 and 500 U/L], autopsies showing submassive necrosis and microvesicular steatosis).
Donat JF, Bocchini JA, Gonzalez E, Schwendimann RN. (1979). Valproic acid and fatal hepatitis. Neurology. (17 month old child with seizures developed jaundice one month after starting valproate [bilirubin 4.4 mg/dL, AST 130 U/L, ammonia 266 IU/L], progressing to hepatic failure and death one week later, autopsy showing changes suggestive of "viral or drug-induced hepatitis").
Mathis RK, Hanson RF, Sharp HL. (1979). Hepatic failure from valproic acid. N Engl J Med. (Letter in response to Suchy [1979] argues for mitochondrial injury as the cause of valproate hepatotoxicity, in that electron microscopy of liver biopsies from two children showed enlarged mitochondria with decreased matrix density, altered cristae, and increase in dense bodies).
Gerber N, Dickinson RG, Harland RC, Lynn RK, Houghton LD, Antonias JI, Schimschock JC. (1979). Reye-like syndrome associated with valproic acid therapy. J Pediatr. (12 year old girl developed fatigue and fever followed by progressive coma 2 months after starting valproate [bilirubin 1.3 mg/dL, ALT 78 U/L, prothrombin time 17 sec, ammonia 204 μmol/L], with acidosis, progressive coma and death; autopsy showing microvesicular fat in hepatocytes and renal tubular cells and centrolobular necrosis indicative of Reye syndrome).
Jacobi G, Thorbeck R, Ritz A, Janssen W, Schmidts HL. (1980). Fatal hepatotoxicity in child on phenobarbitone and sodium valproate. Lancet. (7 year old boy developed lethargy followed by coma 3 months after starting valproate [bilirubin rising to 17.5 mg/dL, ALT 60 U/L, ammonia 455 μmol/L], with acidosis and death, autopsy showing hepatic steatosis, centrolobular necrosis and cholestasis).
Ware S, Millward-Sadler GH. (1980). Acute liver disease associated with sodium valproate. Lancet. (Five patients with valproate hepatotoxicity; 4 children, ages 2 to 9 years, treated with valproate for 3-5 months, developed acute liver injury, autopsies showing acute hepatic necrosis and microvesicular steatosis).
(1980). Sodium valproate and the liver. Lancet. (Editorial in response to Ware [1980] commenting on the many reports of fatal valproate hepatotoxicity in young children with features of Reye syndrome).
Le Bihan G, Bourreille J, Sampson M, Leroy J, Szekely AM, Coquerel A. (1980). Fatal hepatic failure and sodium valproate. Lancet. (17 year old girl developed fatigue 3 months after starting valproate [bilirubin 1.9 mg/dL, ALT 161 U/L, Alk P 190 U/L, prothrombin time 20 sec], with progressive hepatic failure, ascites, encephalopathy and liver transplant 1 month later).
Young RS, Bergman I, Gang DL, Richardson EP. (1980). Fatal Reye-like syndrome associated with valproic acid. Ann Neurol. (8 year old boy developed worsening seizures, fever and stupor 3 weeks after starting valproate [bilirubin not given, AST 564 U/L, ammonia 354 ug/dL], with hypoglycemia, acidosis and death within days, autopsy showing microvesicular fat in liver and renal tubules).
Coulter DL, Allen RJ. (1981). Hyperammonemia with valproic acid therapy. J Pediatr. (Among "several hundred" children being treated with valproate, 11 developed stupor or coma, 8 of whom had elevated ammonia levels [mean 118.2 μmol/L], six of whom had normal liver tests and recovered within 1-3 days of stopping valproate, some tolerating lower doses).
Gastaut H, Noel P. (1981). A case of fatal toxic hepatitis: recommendations for the administration of sodium valproate. Epilepsia. (2 year old boy developed stupor and coma 5 months after starting valproate [bilirubin 3 mg/dL, ALT 1975 U/L, ammonia 132 μg/dL], with progressive liver failure and death 5 days later, autopsy showing "ballooned hepatocytes with a clear cytoplasm but no steatosis").
Zimmerman HJ, Ishak KG. (1982). Valproate-induced hepatic injury: analyses of 23 fatal cases. Hepatology. (Review of 23 fatal cases of valproate liver injury: ages 1 to 28 years, 56% male, onset after <1-4 months of 13-71 mg/kg/day; most patients were taking other anticonvulsants; symptoms were fatigue followed by jaundice, ascites and coma; no rash or eosinophilia; ALT levels were usually <300 U/L, AST>ALT, bilirubin 1.0-36 mg/dL, protime and ammonia usually elevated. Histology showed microvesicular steatosis, centrizonal and ballooning necrosis; some patients already had cirrhosis).
Zafrani ES, Berthelot P. (1982). Sodium valproate in the induction of unusual hepatotoxicity. Hepatology. (Editorial in response to Zimmerman and Ishak [1982] describing 31 fatal cases from Europe, ages 9 months to 29 years, twice as common in children than adults, no rash or eosinophilia, onset with vomiting and weakness, jaundice late, ALT not very high, histology showing fat and centrilobular necrosis).
Stricker BH. (1982). Ned Tijdschr Geneeskd. (Review of valproate hepatotoxicity, mentioning that there have been at least 50 fatal cases reported in the literature, clinical features can resemble Reye syndrome and liver histology reveals microvesicular steatosis and centrolobular necrosis).
Ohtani Y, Endo F, Matsuda I. (1982). Carnitine deficiency and hyperammonemia associated with valproic acid therapy. J Pediatr. (Testing of 14 patients on valproate and 11 on other anticonvulsants for carnitine levels reported low levels in those on valproate [33 vs 49 nM], correlating with dose and with ammonia levels; carnitine supplementation was associated with rapid decrease in ammonia levels, from 144 to 71 μg/dL).
Itoh S, Yamaba Y, Matsuo S, Saka M, Ichinoe A. (1982). Sodium valproate-induced liver injury. Am J Gastroenterol. (37 year old woman developed fever and abdominal pain 1 month after starting valproate [bilirubin 2.2 mg/dL, ALT 1550 U/L, Alk P 206 U/L], with rapid improvement upon stopping and sharp rise in rise in bilirubin and ALT within one day of rechallenge; liver biopsy showed microvesicular steatosis, crystalline inclusions in mitochondria and marked centrilobular necrosis).
Zaret BS, Beckner RR, Marini AM, Wagle W, Passarelli C. (1982). Sodium valproate-induced hyperammonemia without clinical hepatic dysfunction. Neurology. (3 cases of hyperammonemia in adults taking valproate, ages 20 to 51 years, onset days to years after starting, ammonia 56-146 μM, rapid reversal with stopping).
Böhles H, Richter K, Wagner-Thiessen E, Schafer H. (1982). Decreased serum carnitine in valproate induced Reye syndrome. Eur J Pediatr. (3 year old girl developed fatal liver injury ~3 months after starting valproate [bilirubin 4.3 rising to 23 mg/dL, ALT 34 to 82 U/L, Alk P 350 U/L, ammonia 89 μg/dL, glucose 23 mg/dL, low carnitine levels and abnormal valproate metabolites]; hypothesized that injury was due to carnitine deficiency related inhibition of mitochondrial beta oxidation).
Sugimoto T, Nishida N, Yasuhara A, Ono A, Sakane Y, Matsumura T. (1983). Reye-like syndrome associated with valproic acid. Brain Dev. (13 year old girl on chronic valproate therapy had seizures and was admitted in shock with high serum ammonia 400 µM, ALT 1454 U/L, bilirubin 1.2 mg/dL, LDH 29,184 U/L, died 3 days later; questioned whether it was due to Reyes syndrome vs ischemic hepatitis).
de Wolff FA, Peters AC, van Kempen GM. (1983). The effects of valproic acid on liver function. Arch Toxicol Suppl. (Serum levels of GGT were not elevated in 32 children with epilepsy being treated with valproate).
Perucca E, Hedges A, Makki KA, Ruprah M, Wilson JF, Richens A. (1984). A comparative study on the relative enzyme inducing properties of anticonvulsant drugs in epileptic patients. Br J Clin Pharmacol. (Cross sectional study of antipyrine clearance in 122 patients with epilepsy, found dose dependent increase in clearance in those on phenytoin, phenobarbital and carbamazepine, but not on valproate).
Keene DL, Humphreys P, Carpenter B, Fletcher JP. Valproic acid producing a Reye-like syndrome. J Canad Sci Neurol 1982; 435-7. (3 year old boy with severe seizure disorder and status epilepticus developed coma and acute liver failure on valproate [2 years], phenytoin and ethosuximide with AST >4500 U/L, normal bilirubin and valproate levels; subsequently had worsening neurological status, liver biopsy showing macro and microvesicular fat, ballooning, cholestasis and inflammation, similar but not completely typical of Reyes syndrome).
Coulter DL. (1984). Carnitine deficiency: a possible mechanism for valproate hepatotoxicity. Lancet. (Letter in which author proposes that valproate lowers carnitine levels, which impairs metabolism of fatty acids and mitochondrial function causing hyperammonemia and liver injury, recommends supplementation).
Green SH. (1984). Sodium valproate and routine liver function tests. Arch Dis Child. (Editorial suggesting that monitoring liver tests is unlikely to be helpful in predicting idiosyncratic reactions to valproate).
Powell-Jackson PR, Tredger JM, Williams R. (1984). Hepatotoxicity to sodium valproate: a review. Gut. (Review of literature and own cases of valproate liver injury; describe three forms, hepatitis-like syndrome arising 4-16 weeks after starting therapy with high fatality rate; a Reyes-like syndrome and hyperammonemia with minimal liver injury).
Murphy JV, Marquardt KM, Shug AL. (1985). Valproic acid associated abnormalities of carnitine metabolism. Lancet. (6 month old infant with Reyes-like syndrome [ALT 9690 U/L] had low carnitine levels that increased with recovery; testing 13 asymptomatic children on valproate found low levels ~40 μM compared to 50 μM in controls).
Blaw ME, Belknap WM. (1985). Valproate hepatotoxicity. Pediatr Neurol. (Report a fatal case of valproate hepatotoxicity [no specific information given], recommending prompt investigation if symptoms develop on valproate, particularly during first month of therapy).
Dickinson RG, Bassett ML, Searle J, Tyrer JH, Eadie MJ. (1985). Valproate hepatotoxicity: a review and report of two instances in adults. Clin Exp Neurol. (Review of literature and 2 case reports; 19 year old male with drowsiness starting 2 months after increasing valproate dose [bilirubin ~5.0 mg/dL, AST 3x ULN, Alk P ~4x ULN], resolving rapidly upon stopping; 25 year old man with liver injury arising 1 month after starting valproate with biopsy showing centrolobular necrosis).
Møller P, Henriksen O. (1986). Tidsskr Nor Laegeforen. (27 year old man developed agitation within days of starting valproate [ALT 313 U/L, bilirubin and Alk P normal], which rapidly improved on stopping, but the patient died suddenly 6 weeks later).
Ratnaike RN, Schapel GJ, Purdie G, Rischbieth RHC, Hoffmann S. (1986). Hyperammonaemia and hepatotoxicity during chronic valproate therapy: enhancement by combination with other antiepileptic drugs. Br J Clin Pharmacol. (Cross sectional analysis of ammonia levels and liver tests in 81 patients with epilepsy; higher average levels of ammonia in patients on valproate [37.1 vs 28.7 μmol], slightly higher rate of elevations in those receiving other agents [phenytoin, carbamazepine] as well).
Colletti RB, Trainer TD, Krawisz BR. (1986). Reversible valproate fulminant hepatic failure. J Pediatr Gastroenterol Nutr. (12 year old boy developed fever and rash followed by confusion 2-3 months after starting valproate [bilirubin 4.6 mg/dL, ALT 2425 U/L, Alk P 289 U/L, ammonia 66 μmol/L, prothrombin time 15 sec], improvement beginning a week after stopping, values ultimately normal; liver biopsy showing microvesicular steatosis and focal necrosis).
Laub MC, Paetzke-Brunner I, Jaeger G. (1986). Serum carnitine during valproic acid therapy. Epilepsia. (Cross sectional study of 21 patients on valproate, 21 on other anticonvulsants, and 21 controls; found lower carnitine levels in patients on valproate, but small differences and no response in one patient with fatal hyperammonemia).
Dreifuss FE. (1987). Fatal liver failure in children on valproate. Lancet. (Letter pointing out safety of valproate if used in children above the age of 2, without familial history of liver disease, in low doses without concurrent aspirin or during febrile illness and rapid investigation of symptoms).
Scheffner D, König S, Rauterberg-Ruland I, Kochen W, Hofmann WJ, Unkelbach S. (1988). Fatal liver failure in 16 children with valproate therapy. Epilepsia. (Analysis of 16 patients with fatal valproate hepatotoxicity in Germany between 1977 and 1987; ages 1-17, 6 on monotherapy, onset occurred mostly in first 6 months; typical presentation with nausea, abdominal pain and apathy followed by jaundice, biopsies show micro- and macro-vesicular fat and centrilobular necrosis, often with fibrosis; estimated fatality rate 1:5,000, recommended monitoring for first 6 months).
Dreifuss FE, Santilli N, Langer DH, Sweeney KP, Moline KA, Menander KB. (1987). Valproic acid hepatic fatalities: a retrospective review. Neurology. (Review of all the reports of fatal liver injury from valproate reported to drug company and FDA between 1978 and 1984 found 37 cases; highest number in children <2 years, with coincidental neurologic problems and polytherapy with other anticonvulsants; onset usually within first 90 days; variable presentations and laboratory abnormalities).
Iinuma K, Hayasaka K, Narisawa K, Tada K, Hori K. (1988). Hyperamino-acidaemia and hyperammonaemia in epileptic children treated with valproic acid. Eur J Pediatr. (Among 75 children with epilepsy, serum ammonia levels were elevated in 20% [8/41] of those on valproate, but in none of 34 children taking other anticonvulsants).
Dreifuss FE, Langer DH, Moline KA, Maxwell JE. (1989). Valproic acid hepatic fatalities. II. US experience since 1984. Neurology. (During further follow up of national data, there was an increase use of valproate, but a decrease in incidence of valproate hepatotoxicity; thus in 1985-86, only four cases were identified, 3 with polytherapy, 3 in children with other medical conditions, clinical onset occurred after 60-105 days of therapy).
Kuhara T, Inoue Y, Matsumoto M, Shinka T, Matsumoto I, Kawahara N, Sakura N. (1990). Markedly increased omega-oxidation of valproate in fulminant hepatic failure. Epilepsia. (Abnormal metabolites of valproate found in urine of child with fatal Reyes-like syndrome on long term valproate [ALT 5330, LDH 18405, ammonia 212 mg/L and rising bilirubin], abnormalities suggested increase in P-450 metabolism of valproate).
Appleton RE, Farrell K, Applegarth DA, Dimick JE, Wong LT, Davidson AG. (1990). The high incidence of valproate hepatotoxicity in infants may relate to familial metabolic defects. Can J Neurol Sci. (Two unrelated infants developed fatal, acute liver failure after 2-3 days of valproate, both had siblings with developmental delay and liver abnormalities and steatosis not on valproate, suggesting that valproate may not have been responsible for liver injury in the index patients).
Wyllie E, Wyllie R. (1991). Routine laboratory monitoring for serious adverse effects of antiepileptic medications: the controversy. Epilepsia. (The effectiveness of monitoring serum enzyme levels in patients starting anticonvulsant therapy in preventing acute liver failure is controversial and unproven; this approach is most appropriate for valproate, but probably only during the first 6 months and in high risk subjects).
Binek J, Hany A, Egloff B, Heer M. (1991). Schweiz Med Wochenschr. (21 year old man developed jaundice 12 weeks after starting valproate [bilirubin 10.2 mg/dL, ALT 500 U/L, Alk P 348 U/L, prothrombin index 19%], followed by progressive multiorgan failure and death; autopsy showing massive necrosis and steatosis).
Bell EA, Shaefer MS, Markin RS, Wood RP, Langnas AN, Stratta RJ, Shaw BW. (1992). Treatment of valproic acid-associated hepatic failure with orthotopic liver transplantation. Ann Pharmacother. (23 year old woman developed lethargy and confusion followed by coma 6 weeks after starting valproate [bilirubin 3.1 mg/dL, ALT 10,640 U/L, Alk P 197 U/L, prothrombin time 54 sec, ammonia 127 umol/L], with severe metabolic acidosis and progressive liver failure, undergoing liver transplant within 48 hours of presentation).
Murphy JV, Groover RV, Hodge C. (1993). Hepatotoxic effects in a child receiving valproate and carnitine. J Pediatr. (17 month old child with developmental delay developed severe liver injury arising 9 weeks after starting valproate [bilirubin 2.3 rising to 26.5 mg/dL, ALT 552 U/L, Alk P 360 U/L, prothrombin time 24.7 sec], with progressive hepatic failure and death 6 weeks later, autopsy showing massive necrosis and fibrosis).
Siemes H, Nau H, Schultze K, Wittfoht W, Drews E, Penzien J, Seidel U. (1993). Valproate (VPA) metabolites in various clinical conditions of probable VPA-associated hepatotoxicity. Epilepsia. (Analysis of plasma valproate levels and its metabolites in 470 patients with epilepsy found no consistent level or pattern of metabolites in patients with liver injury compared to those without).
König SA, Simes H, Blaker F, Boenigk E, Gross-Selbeck G, Hanefeld F, Haas N, et al. (1994). Severe hepatotoxicity during valproate therapy: an update and report of eight new fatalities. Epilepsia. (Review and update of fatal cases of valproate hepatotoxicity from Germany-Switzerland, risk factors were found to be age <2 years and cases were rare in patients above 18 years; onset can occur >6 months after onset, often presenting with worsening seizures, nausea and apathy after a febrile illness).
Plantin P, Cartier H, Le Bihan G, Clouard P, Lellouche F, Leroy JP. (1995). Presse Med. (41 year old woman developed fever followed by rash 6 weeks after starting valproate [bilirubin 6.0 mg/dL, ALT 559 U/L, eosinophils 20%], resolving within 4 weeks of stopping).
Krähenbühl S, Mang G, Kupferschmidt H, Meier PJ, Krause M. (1995). Plasma and hepatic carnitine and coenzyme A pools in a patient with fatal, valproate induced hepatotoxicity. Gut. (39 year old woman with bipolar disorder developed stupor 4 months after starting valproate [bilirubin 8.5 mg/dL, ALT 35 U/L, prothrombin index 39%, ammonia 75 µmol/L] and deteriorated after a “cardiovascular collapse”, dying of multiorgan failure).
Böhles H, Sewell AC, Wenzel D. (1996). The effect of carnitine supplementation in valproate-induced hyperammonaemia. Acta Paediatr. (In an uncontrolled study, carnitine supplementation was followed by decreases in ammonia levels and increases in free carnitine levels in 14 patients with hyperammonia on valproate).
Bryant AE, Dreifuss FE. (1996). Valproic acid hepatic fatalities, III: US experience since 1986. Neurology. (Third retrospective study of US experience with fatal hepatotoxicity from valproate summaries 29 cases; risk factors were age <2 years and polytherapy [~1:600 treated subjects]; risk decreased with age so that in adults risk is ~1:30,000, but risk in adults also increased with polytherapy).
Wallace SJ. (1996). A comparative review of the adverse effects of anticonvulsants in children with epilepsy. Drug Saf. (Systematic review; ALT elevations occur in 4% of children on phenytoin, 6% on valproate, 1% on carbamazepine and not reported on tiagabine or gabapentin).
Schwabe MJ, Dobyns WB, Burke B, Armstrong DL. (1997). Valproate-induced liver failure in one of two siblings with Alpers disease. Pediatr Neurol. (Siblings with Alpers syndrome developed progressive developmental delay and seizures, one dying of acute liver failure 1 month after starting valproate).
Pessayre D, Mansouri A, Haouzi D, Fromenty B. (1999). Hepatotoxicity due to mitochondrial dysfunction. Cell Biol Toxicol. (Review of the role of mitochondrial dysfunction in drug induced liver injury focusing upon valproate).
Hamer HM, Morris HH. (1999). Hypersensitivity syndrome to antiepileptic drugs: a review including new anticonvulsants. Cleve Clin J Med. (Hypersensitivity occurs in 1-5/10,000 users of aromatic anticonvulsants, higher risk in African Americans and affected siblings; liver involvement common, but most cases anicteric; other manifestations include facial edema, lymphadenopathy, bone marrow aplasia, pseudolymphoma, thyroiditis, interstitial nephritis).
McLaughlin DB, Eadie MJ, Parker-Scott SL, Addison RS, Henderson RD, Hooper WD, Dickinson RG. (2000). Valproate metabolism during valproate-associated hepatotoxicity in a surviving adult patient. Epilepsy Res. (Valproate is a simple branched chain fatty acid, but has complex metabolism undergoing β-oxidation; 33 year old man developed jaundice and marked ALT elevations [~100x ULN] 7 months after starting valproate, initially had high oxo-VPA relative to valproate suggesting impaired β-oxidation and mitochondrial dysfunction; cause or effect unclear).
Picart N, Périole B, Mazereeuw J, Bonafé JL. (2000). Presse Med. (28 year old woman developed fever and maculo-papular generalized rash 3 weeks after starting valproate with adenopathy, eosinophilia and ALT 176 U/L, but normal bilirubin and Alk P, rapid resolution and positive skin reaction to valproate 4 months later).
Delarue A, Paut O, Guys JM, Montfort MF, Lethel V, Roquelaure B, Pellissier JF, et al. (2000). Inappropriate liver transplantation in a child with Alpers-Huttenlocher syndrome misdiagnosed as valproate-induced acute liver failure. Pediatr Transplant. (3 year old boy developed acute liver failure within a few months of starting valproate for seizures [bilirubin not given; ALT 196 U/L, prothrombin index 24%], with progressive hepatic failure and liver transplantation within 3 weeks of onset, child dying 4 months later of progressive neurological deterioration).
Kayihan N, Nennesmo I, Ericzon BG, Németh A. (2000). Fatal deterioration of neurological disease after orthotopic liver transplantation for valproic acid-induced liver damage. Pediatr Transplant. (13 year old girl with progressive neurologic disease since age 3 to 5 years developed acute liver failure 5 months after starting valproate leading to liver transplantation, with subsequent rapid neurological deterioration and death 6 months later).
Thomson MA, Lynch S, Strong R, Shepherd RW, Marsh W. (2000). Orthotopic liver transplantation with poor neurologic outcome in valproate-associated liver failure: a need for critical risk-benefit appraisal in the use of valproate. Transplant Proc. (5 children, ages 1 to 4 years, with acute liver failure from valproate [onset after 2-4 months] had poor neurological outcomes after liver transplantation, explant showing microvesicular steatosis and massive necrosis).
Spahr L, Negro F, Rubbia-Brandt L, Marinescu O, Goodman K, Jordan M, Frossard JL, Hadenque A. (2001). Acute valproate-associated microvesicular steatosis: could the [13C]methionine breath test be useful to assess liver mitochondrial function?. Dig Dis Sci. (24 year old woman took an overdose of valproate [~7 grams] and presented with drowsiness and marked rise in ALT and fall in prothrombin over next 2 days, but without jaundice; liver biopsy showed microvesicular steatosis and swollen mitochondria, abnormal C-methionine breath test, rapidly improved).
Chen WT, Yen DJ, Yu HY, Liao KK. (2001). Valproate-induced encephalopathy. Zhonghua Yi Xue Za Zhi (Taipei).
Lott RS, Helmboldt KM, Madaras-Kelly KJ. (2001). Retrospective evaluation of the effect of valproate therapy on transaminase elevations in patients with hepatitis C. Pharmacotherapy. (Serial ALT levels in 214 HCV positive patients, 28 on valproate, found no correlation with valproate use).
Barrueto F, Hack JB. (2001). Hyperammonemia and coma without hepatic dysfunction induced by valproate therapy. Acad Emerg Med. (41 year old man developed altered mental status while on chronic valproate therapy [3 years], with ammonia of 377 µM but normal liver tests and normal valproate levels).
Bohan TP, Helton E, McDonald I, König SA, Gazitt S, Sugimoto T, Scheffner D, et al. (2001). Effect of L-carnitine treatment for valproate-induced hepatotoxicity. Neurology. (Analysis of 123 patients with valproate hepatotoxicity in international registry demonstrating marked improvement in survival with use of carnitine; there was 100% survival if iv carnitine was started within 5 days of symptomatic onset, compared to >80% fatality rate before introduction of carnitine).
DeVivo DC. (2002). Effect of L-carnitine treatment for valproate-induced hepatotoxicity. Neurology. (Letter in response to Bohan et al. suggesting routine oral carnitine supplementation in patients on valproate).
Clarkson A, Choonara I. (2002). Surveillance for fatal suspected adverse drug reactions in the UK. Arch Dis Child. (Between 1964 and 2002 in the UK, there were 331 reported deaths in children due to medications, including 50 due to liver failure, 21 of which were attributed to valproate).
Longin E, Teich M, Koelfen W, König S. (2002). Topiramate enhances the risk of valproate-associated side effects in three children. Epilepsia. (3 children, ages 1-9 years on valproate for few months to 5 years developed apathy and hypothermia 4-8 weeks after adding topiramate with ammonia elevations [one with ALT elevation as well], rapidly reversed by stopping either agent, positive rechallenge in one; topiramate appears to enhance risk of hyperammonemia due to valproate).
Vossler DG, Wilensky AJ, Cawthon DF, Abson Kraemer DL, Ojemann LM, Caylor LM, Morgan JD. (2002). Serum and CSF glutamine levels in valproate-related hyperammonemic encephalopathy. Epilepsia. (In assessing 7 patients with hyperammonemia on valproate, elevations in glutamine found in CSF; serum valproate levels were usually normal).
Huang Y-L, Hong H-S, Wang Z-W, Kuo T-T. (2003). Fatal sodium valproate-induced hypersensitivity syndrome with lichenoid dermatitis and fulminant hepatitis. J Am Acad Dermatol. (2 year old girl treated with valproate for myoclonic jerks developed fever and rash after 17 days followed by jaundice [bilirubin 37.8 mg/dL, ALT 3037 U/L, protime 50.2 sec], progressing to acute liver failure and death; biopsy showing microvesicular steatosis and necrosis).
Romero-Falcón A, de la Santa-Belda E, García-Contreras R, Varela JM. (2003). A case of valproate-associated hepatotoxicity treated with L-carnitine. Eur J Intern Med. (16 year old male developed lethargy and jaundice 6 weeks after starting valproate for epilepsy [bilirubin 21 mg/dL, AST 3887 U/L, Alk P 406 U/L, normal valproate levels], given carnitine and recovered in ~3 weeks).
Ee LC, Shepherd RW, Cleghorn GJ, Lewindon PJ, Fawcett J, Strong RW, Lynch SV. (2003). Acute liver failure in children: A regional experience. J Paediatr Child Health. (Among 26 children with acute liver failure referred to the Queensland Transplant Service between 1984 and 2000; 2 were transplanted for valproate liver injury, both of whom subsequently died of neurological disease despite good graft function).
Arévalo-Lorido JC, Carretero-Gómez J, Bureo-Dacal JC, Montero-Leal C, Bureo-Dacal P. (2003). Antiepileptic drug hypersensitivity syndrome in a patient treated with valproate. Br J Clin Pharmacol. (36 year old man developed fever, rash, eosinophilia and lymphadenopathy 1 month after starting carbamazepine, improving with corticosteroid therapy, but recurring when valproate was started 2 weeks later).
Bumb A, Diederich N, Beyenburg S. (2003). Adding topiramate to valproate therapy may cause reversible hepatic failure. Epileptic Disord. (51 year old woman with resistant epilepsy had topiramate added to valproate and developed confusion and liver injury [bilirubin not given, ALT 464 U/L, GGT 569 U/L, ammonia 88 μg/dL], improved on withdrawal of valproate; hypothesized that topiramate changed pharmacokinetics of valproate).
Nakazato Y, Ando S, Yamamoto T, Tamura N, Shimazu K. (2004). Rinsho Shinkeigaku.
McCall M, Bourgeois JA. (2004). Valproic acid-induced hyperammonemia: a case report. J Clin Psychopharmacol. (62 year old woman on long term valproate developed dizziness, fatigue and confusion with normal valproate levels but 3 fold elevation in ammonia, minimal AST elevation, improvement with stopping; unclear what triggered the event).
Yehya N, Saldarini CT, Koski ME, Davanzo P. (2004). Valproate-induced hyperammonemic encephalopathy. J Am Acad Child Adolesc Psychiatry. (9 year old boy with severe behavioral problems developed recurrent episodes of confusion and aggression on valproate with elevated ammonia levels improving with stopping valproate, liver tests normal).
Luef GJ, Waldmann M, Sturm W, Naser A, Trinka E, Unterberger I, Bauer G, et al. (2004). Valproate therapy and nonalcoholic fatty liver disease. Ann Neurol. (Among 45 patients with epilepsy, ultrasound showed fatty liver in 63% of patients on valproate but only 23% on carbamazepine; ALT and AST similar, insulin resistance and overweight were more common with valproate treatment).
Lokrantz CM, Eriksson B, Rosén I, Asztely F. (2004). Hyperammonemic encephalopathy induced by a combination of valproate and pivmecillinam. Acta Neurol Scand. (72 year old woman on valproate for 8 months developed stupor and coma 2 weeks after starting pivmecillinam for urinary tract infection [liver tests normal, ammonia 113 µM], pivmecillinam known to decrease carnitine levels).
Weng TI, Shih FF, Chen WJ. (2004). Unusual causes of hyperammonemia in the ED. Am J Emerg Med. (Four case reports demonstrating various causes of hyperammonemia without liver disease; partial ornithine carbamoyltransferase deficiency, anticancer chemotherapy and valproate).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, of which 10 were attributed to phenytoin, 10 to valproate and 1 to carbamazepine, but none to any other anticonvulsants).
Roepke S, Treudler R, Anghelescu I, Orfanos CE, Tebbe B. (2004). Valproic Acid and hypersensitivity syndrome. Am J Psychiatry. (48 year old man developed fever, rash and lymphadenopathy 3 weeks after starting valproate with eosinophilia [24%] and slight elevations in “levels of transaminases”, resolving with corticosteroid therapy).
Rahman M, Haider N. (2005). Anticonvulsant hypersensitivity syndrome from addition of lamotrigine to divalproex. Am J Psychiatry. (50 year old woman with bipolar disorder on valproate developed fever, rash and eosinophilia [5%] 2-3 weeks after starting lamotrigine [bilirubin and Alk P normal, ALT 186 U/L], resolving soon after stopping both valproate and lamotrigine).
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. (2005). Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol. (36 years of reporting to Swedish registry identified 103 cases of acute liver failure due to drugs; valproate listed as causing only one case).
Lheureux PE, Penaloza A, Zahir S, Gris M. (2005). Science review: carnitine in the treatment of valproic acid-induced toxicity–what is the evidence?. Crit Care. (Review of literature on efficacy of carnitine in reversing toxicity of valproate overdose, acute liver injury and hyperammonemia; efficacy largely based on use of historical controls).
Ortiz-Sáenz de Santa María R, Santiago-Fernández C, Cano-Del Pozo M, et al. (2005). Rev Neurol.
Cuturic M, Abramson RK. (2005). Acute hyperammonemic coma with chronic valproic acid therapy. Ann Pharmacother. (56 year old woman on long term valproate for epilepsy developed episodic confusion after minor increase in valproate dose and stopping other agents; valproate dose increased and patient worsened and found to have high ammonia with normal liver tests).
Sato K, Ueda Y, Ueno K, Okamoto K, Iizuka H, Katsuda S. (2005). Hepatocellular carcinoma and nonalcoholic steatohepatitis developing during long-term administration of valproic acid. Virchows Arch. (64 year old man treated with valproate for 17 years developed hepatocellular carcinoma with steatosis, Mallory bodies and bridging fibrosis, possibly related to nonalcoholic steatohepatitis).
Rath A, Naryanan TJ, Chowdhary GV, Murthy JM. (2005). Valproate-induced hyperammonemic encephalopathy with normal liver function. Neurol India. (Review of 5 cases of hyperammonemia on valproate; 3 monotherapy, onset after 4-90 days with decreased sensorium, episodic vomiting, all had normal ALT, resolved with stopping without use of carnitine).
Bauer MS. (2005). Fatal hepatic failure and valproate. Am J Psychiatry. (51 year old man with bipolar disorder developed jaundice 3 months after starting valproate with previously normal liver tests [bilirubin 9.1 mg/dL, ALT 3208 U/L, Alk P 172 U/L, protime 18.8 sec], died awaiting liver transplantation).
Kimmel RJ, Irwin SA, Meyer JM. (2005). Valproic acid-associated hyperammonemic encephalopathy: a case report from the psychiatric setting. Int Clin Psychopharmacol. (50 year old woman on long term valproate for psychiatric reasons developed confusion and coma with high ammonia levels 4 months after adding lamotrigine, responding to stopping therapy).
Koenig SA, Buesing D, Longin E, Oehring R, Haussermann P, Kluger G, Lindmayer F, et al. (2006). Valproic acid-induced hepatopathy: nine new fatalities in Germany from 1994 to 2003. Epilepsia. (Survey of all German members of International League Against Epilepsy identified 31 cases of valproate liver injury between 1994 and 2003; 9 fatal and 22 recovered cases; latency of 1-6 months, ALT 113-2160 U/L).
Kakinuma H, Fujiki T, Nakamura T, Takahashi H. (2006). Valproate hepatotoxicity in a 5-year-old boy with cerebral palsy due to neonatal asphyxia. Pediatr Int. (5 year old boy with cerebral palsy had fever and status epilepticus and was treated with valproate, developing acute liver failure within a few days [bilirubin initially 1.0 mg/dL, ALT 8290 U/L, NH3 112 μg/mL], slow recovery and neurological residual; no metabolic abnormality found).
Björnsson E, Olsson R. (2006). Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis. (In WHO database of fatal adverse drug reactions from 1968-2003 there were 4690 reports of drug induced liver fatality: valproate was the third most common cause [~130 cases]).
Tzoulis C, Engelsen BA, Telstad W, Aasly J, Zeviani M, Winterthun S, Ferrari G, et al. (2006). The spectrum of clinical disease caused by the A467T and W748S POLG mutations: a study of 26 cases. Brain. (Clinical features of patients with p.A467T and/or p.W748S variants in DNA polymerase gamma; onset of epilepsy, headache, ataxia or speech delay usually in the teen years with relentless course of myoclonus and ataxia, 2 died of liver failure, but 7 developed acute liver failure after valproate therapy of seizures).
Horvath R, Hudson G, Ferrari G, Futterer N, Ahola S, Lamantea E, Prokisch H, et al. (2006). Phenotypic spectrum associated with mutations of the mitochondrial polymerase gamma gene. Brain. (Analysis of “large number” of patients with suspected mitochondrial disease [Alpers, familial progressive external ophthalmoplegia, late onset ataxia] for the mitochondrial DNA polymerase gamma sequence; identified frequent but heterogenous variants, p.A467T being common with encephalopathy and liver disease [often triggered by valproate], but found in other syndromes).
Alqahtani S, Federico P, Myers RP. (2007). A case of valproate-induced hyperammonemic encephalopathy: look beyond the liver. CMAJ. (18 year old woman developed stupor and asterixis 2 weeks after starting valproate, with high ammonia levels and normal liver tests, and recovery within a week after stopping).
Wadzinski J, Franks R, Roane D, Bayard M. (2007). Valproate-associated hyperammonemic encephalopathy. J Am Board Fam Med. (2 women, ages 29 and 51, developed hyperammonemia with confusion after 7 days and 5 months of high doses of valproate [normal bilirubin and ALT], with rapid improvement on stopping).
Velioğlu SK, Gazioğlu S. (2007). Non-convulsive status epilepticus secondary to valproic acid-induced hyperammonemic encephalopathy. Acta Neurol Scand. (19 year old male developed stupor, coma and seizures 4 days after starting valproate, found to have high ammonia levels with normal ALT, bilirubin and valproate levels, resolving with stopping).
Carr RB, Shrewsbury K. (2007). Hyperammonemia due to valproic acid in the psychiatric setting. Am J Psychiatry. (45 year old woman treated with valproate for psychiatric disorder developed confusion after 6 days, later found with high ammonia levels despite normal ALT levels, improvement with stopping).
Attilakos A, Voudris KA, Katsarou E, Prassouli A, Mastroyianni S, Garoufi A. (2007). Transient decrease in serum albumin concentrations in epileptic children treated with sodium valproate monotherapy. Clin Neuropharmacol. (26 children given valproate were monitored with liver tests at 0, 6, 12 and 24 months: only 1 had abnormal ALT [44 U/L], GGT normal in all, minimal overall increase in ALT and AST and decrease in albumin levels).
Tang W. (2007). Drug metabolite profiling and elucidation of drug-induced hepatotoxicity. Expert Opin Drug Metab Toxicol. (Review of role of drug metabolic studies in elucidating cause of hepatotoxicity).
Chicharro AV, de Marinis AJ, Kanner AM. (2007). The measurement of ammonia blood levels in patients taking valproic acid: looking for problems where they do not exist?. Epilepsy Behav. (Review of literature on ammonia levels in patients on valproate, consistent finding of levels increasing 2 fold, but usually without symptoms and not requiring dose modification).
Russell S. (2007). Carnitine as an antidote for acute valproate toxicity in children. Curr Opinion Pediatr. (Short review of valproate toxicity and clinical use of carnitine).
Gerstner T, Bauer MO, Longin E, Bell N, Koenig SA. (2007). Reversible hepatotoxicity, pancreatitis, coagulation disorder and simultaneous bone marrow suppression with valproate in a 2-year-old girl. Seizure. (2 year old girl on valproate for over a year had severe liver injury [bilirubin not given, ALT 2510 U/L, lipase 725 U/L, normal valproate and ammonia levels], resolving upon stopping).
Chou HF, Yang RC, Chen CY, Jong YJ. (2008). Valproate-induced hyperammonemic encephalopathy. Pediatr neonatol. (Adolescent developed dizziness within days of starting valproate, with normal ALT but ammonia five-fold elevated, rapid recovery with stopping).
Tsai M-F, Chen C-Y. (2008). Valproate-induced hyperammonemic encephalopathy treated by hemodialysis. Ren Fail. (14 year old girl developed dizziness within days of restarting higher doses of valproate with high ammonia and valproate levels, but normal ALT and bilirubin; the syndrome reversed within 12 hours with hemodialysis).
Nicolai J, Gunning B, Leroy PL, Ceulemans B, Vles JS. (2008). Acute hepatic injury in four children with Dravet syndrome: valproic acid, topiramate or acetaminophen?. Seizure. (4 children with severe infantile myoclonic epilepsy on chronic therapy with topiramate and valproate had sudden and transient onset of marked elevations in ALT [2229, 5898, 280 and 480 U/L] and hyperammonemia or coagulopathy without jaundice shortly after febrile illness and/or use of acetaminophen; possibly Reye syndrome due to valproate and topiramate, rapid recovery despite continuing anticonvulsants).
Dewan P, Aggarwal A, Faridi MM. (2008). Effect of phenytoin and valproic acid therapy on serum lipid levels and liver function tests. Indian Pediatr. (Cross sectional analysis of lipid and liver test results in 52 children on phenytoin or valproate showing minimal differences between groups).
Subhash HS, Heddle RJ, Schultz DW, Ring J, Thompson CH. (2008). Hepatic encephalopathy precipitated by sodium valproate therapy. Med J Aust. (71 year old woman developed confusion 2 years after starting valproate with no change in liver tests; chronic Alk P elevations subsequently shown to be due to primary biliary cirrhosis).
McFarland R, Hudson G, Taylor RW, Green SH, Hodges S, McKiernan PJ, Chinnery PF, Ramesh V. (2008). Reversible valproate hepatotoxicity due to mutations in mitochondrial DNA polymerase gamma (POLG1). Arch Dis Child. (2 year old boy developed stupor 2 months after starting valproate [bilirubin 0.6 rising to 6.4 mg/dL, ALT 249 U/L], who subsequently developed liver failure but recovered; gene sequencing showed several mutations in DNA polymerase gamma).
Björnsson E. (2008). Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scand. (Review of hepatotoxicity of all anticonvulsants; elevations in ALT or Alk P in up to 44% of users of valproate but serious toxicity occurs in only ~1:15,000 patients, higher in young children; 4 types of injury; asymptomatic enzyme elevations, acute hepatotoxicity, Reye syndrome and hyperammonemia).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, et al., Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, valproate accounted for 6 cases, lamotrigine 5, phenytoin 5, gabapentin and topiramate 1 each).
Neyns B, Hoorens A, Stupp R. (2008). Valproic acid related idiosyncratic drug induced hepatotoxicity in a glioblastoma patient treated with temozolomide. Acta Neurol Belg. (48 year old patient developed cholestatic hepatitis during therapy with temozolomide, cilengitide and valproate, which improved when all drugs were stopped and did not recur with restarting temozolomide).
Mata Zubillaga D, Prieto Espuñes S, Ferrero de la Mano L, Herrero Mendoza B. (2008). An Pediatr (Barc). (7 year old girl developed liver injury on valproate [peak bilirubin 9.5 mg/dL, ALT 2050 U/L, Alk P normal], resolving within a few weeks of stopping).
Verrotti A, Di Marco G, la Torre R, Pelliccia P, Chiarelli F. (2009). Nonalcoholic fatty liver disease during valproate therapy. Eur J Pediatr. (11 year old girl developed nonalcoholic fatty liver disease after 19 kg weight gain attributed to valproate, ALT levels rising from 30 to 80 U/L and returning to normal with weight loss after stopping valproate).
Franciotta D, Kwan P, Perucca E. (2009). Genetic basis for idiosyncratic reactions to antiepileptic drugs. Curr Opin Neurol. (Review of the genetic associations with hypersensitivity reactions to anticonvulsant medications; closest association has been with HLA-B*15:02 and Stevens-Johnson syndrome after aromatic anticonvulsants).
Lheureux PE, Hantson P. (2009). Carnitine in the treatment of valproic acid-induced toxicity. Clin Toxicol (Phila). (Review of the mechanism of action of carnitine in valproate hepatotoxicity and the clinical evidence of its efficacy, concludes that intravenous carnitine "does not appear to be harmful and could be beneficial").
Waring WS, Nixon AC. Acute liver impairment after sodium valproate overdose. BMJ Case Rep 2009; 2009. pii: bcr06.2008.0057. (36 year old woman took an overdose of valproate [32 g] and developed nausea 36 hours later [bilirubin 1.5 mg/dL, ALT 761 U/L], symptoms resolving in 4 days and liver enzymes by 6 weeks).
Stewart JD, Horvath R, Baruffini E, Ferrero I, Bulst S, Watkins PB, Fontana RJ, et al. (2010). Polymerase γ gene POLG determines the risk of sodium valproate-induced liver toxicity. Hepatology. (Among 17 US patients identified with valproate hepatotoxicity, 8 had genetic variations in the mitochondrial DNA polymerase gamma gene, a rate more than 20-fold higher than population controls).
Nishri D, Blumkin L, Lev D, Leshinsky-Silver E, Abu-Rashid M, Birch R, Zuberi SM, Lerman-Sagie T. (2010). Hepatic coma culminating in severe brain damage in a child with a SCN1A mutation. Eur J Paediatr Neurol. (11 month old boy developed status epilepticus and "fulminant liver failure" 2 months after starting valproate for myoclonic epilepsy [bilirubin not given, ALT peak 20,657 U/L, ammonia 380 μmol/L], with brain edema and residual neurologic defects, the mitochondrial DNA polymerase gamma gene was normal but variation found in the alpha-1 subunit gene of the voltage-gated neuronal sodium channel [SCN1A]).
Saneto RP, Lee IC, Koenig MK, Bao X, Weng SW, Naviaux RK, Wong LJ. (2010). POLG DNA testing as an emerging standard of care before instituting valproic acid therapy for pediatric seizure disorders. Seizure. (Among 4 Japanese children with acute liver failure attributed to valproate [3 fatal] seen at a single referral center, two were homozygous for POLG mutations [p.R597W or p.A467T] and two were compound heterozygotes [p.A467T/p.Q68X and p.L83P/p.C888S] indicative of Alpers-Huttenlocher syndrome).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 11 were due to antiepileptic drugs, 2 due to valproate).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; 3 [1.0%] were attributed to valproate, none of which were fatal).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, valproate accounting for 208 cases [2.3%: ranking third] for an adjusted risk odds ratio of 4.0).
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N, Drug-Induced Liver Injury Network. (2011). Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN Prospective Study. J Pediatr Gastroenterol Nutr. (Among 30 children with drug induced liver injury enrolled in a prospective US database between 2004 and 2008, 8 were due to anticonvulsants [lamotrigine in 3, valproate in 3, phenytoin in 1, and carbamazepine in 1], none of which were fatal or led to chronic injury).
Rupasinghe J, Jasinarachchi M. (2011). Progressive encephalopathy with cerebral oedema and infarctions associated with valproate and diazepam overdose. J Clin Neurosci. (29 year old man developed stupor and coma within hours of taking an overdose of valproate [4 g] and diazepam [75 mg], with normal bilirubin and liver enzymes but high ammonia [348 μmol/L], and cerebral edema resulting in residual neurological defects).
Verrotti A, Agostinelli S, Parisi P, Chiarelli F, Coppola G. (2011). Nonalcoholic fatty liver disease in adolescents receiving valproic acid. Epilepsy Behav. (Among 86 adolescents on valproate, fatty liver was present in 36% by ultrasound and in a similar proportion [35%] of 43 weight-matched controls).
Chaudrey KH, Naser TB, Steinberg A, Avashia KD, Nouri-Kolouri M, Asadi S, Irshad Khan SI, Ihsan M. (2012). Thinking beyond the obvious: hepatotoxicity secondary to idiosyncratic depakote toxicity. Am J Ther. (25 year old woman developed confusion while taking valproate and was found to have metabolic acidosis [bilirubin and Alk P not given, ALT 90 U/L, ammonia 143 µmol/L, valproate levels normal], resolving rapidly upon stopping).
Mindikoglu AL, King D, Magder LS, Ozolek JA, Mazariegos GV, Shneider BL. (2011). Valproic acid-associated acute liver failure in children: case report and analysis of liver transplantation outcomes in the United States. J Pediatr. (Among 98 children who underwent liver transplantation for drug induced liver injury in the US between 1987 and 2009, 17 [17%] had valproate induced injury, 15 of whom were less than 8 years old and had poor posttransplant survival compared to controls transplanted for acute liver failure from other agents [20% vs 69% survival at 1 year]).
Tarafdar S, Slee M, Ameer F, Doogue M. (2011). A case of valproate induced hyperammonemic encephalopathy. Case Rep Med. (36 year old man on valproate developed confusion after an alcoholic binge [ammonia 248 µmol/L, valproate levels normal], resolving within 3 days of stopping).
Ghozzi H, Hakim A, Sahnoun Z, Ben Mahmoud L, Atheymen R, Hammami S, Zeghal K. (2011). Rev Neurol (Paris). (In testing 425 patients, no association was found with side effects and plasma levels of valproate).
Pronicka E, Weglewska-Jurkiewicz A, Pronicki M, Sykut-Cegielska J, Kowalski P, Pajdowska M, Jankowska I, et al. (2011). Drug-resistant epilepsia and fulminant valproate liver toxicity. Alpers-Huttenlocher syndrome in two children confirmed post mortem by identification of p.W748S mutation in POLG gene. Med Sci Monit. (Retrospective analysis of 28 children with mitochondrial encephalopathy found p.W748S mutation in the polymerase gamma gene [typical of Alpers-Huttenlocher Syndrome] in two, both of whom died of liver failure a few months after starting valproate for seizures; liver tissue showed mitochondrial depletion).
Cacoub P, Musette P, Descamps V, Meyer O, Speirs C, Finzi L, Roujeau JC. (2011). The DRESS syndrome: a literature review. Am J Med. (Systematic review of literature on DRESS identified 172 cases due to 44 drugs, most frequently carbamazepine [27%], allopurinol [11%] and lamotrigine [6%]; no cases were linked to valproate).
Sedky K, Nazir R, Joshi A, Kaur G, Lippmann S. (2012). Which psychotropic medications induce hepatotoxicity?. Gen Hosp Psychiatry. (Review of hepatotoxicity of psychotropic medications with summary of literature).
Hunter MF, Peters H, Salemi R, Thorburn D, Mackay MT. (2011). Alpers syndrome with mutations in POLG: clinical and investigative features. Pediatr Neurol. (Clinical description of 12 children with Alpers syndrome who were homozygotes or compound heterozygotes for mutations in the polymerase gamma gene; all had developmental delay and seizures starting before 2 years of age and died by age 11, often with cirrhosis or acute liver failure particularly if treated with valproate).
Prins MC, van Meijel JJ. (2011). A case of hyperammonaemic encephalopathy due to valproic acid. Neth J Med. (57 year old man developed progressive stupor while on chronic valproate therapy [liver tests normal, ammonia 132 µmol/L, valproate levels high], resolving rapidly upon stopping).
Bota RG, Ligasan AP, Najdowski TG, Novac A. (2011). Acute hypersensitivity syndrome caused by valproic acid: a review of the literature and a case report. Perm J. (25 year old woman with bipolar disorder developed fever within one week of starting valproate, followed by jaundice and rash [bilirubin 10.2 mg/dL, ALT 767 U/L, Alk P 681 U/L], treated with corticosteroids and resolving within a month of stopping).
Holroyd S, Overdyke JT. (2012). Hyperammonemia associated with valproic acid use in elderly psychiatric patients. J Neuropsychiatry Clin Neurosci. (Retrospective analysis of 12 elderly subjects treated with valproate for 1 to 60 months; liver tests were normal, but 10 [83%] had elevated ammonia levels and 3 had history of confusion or delirium).
Schmid MM, Freudenmann RW, Keller F, Connemann BJ, Hiemke C, Gahr M, Kratzer W, et al. (2013). Non-fatal and fatal liver failure associated with valproic acid. Pharmacopsychiatry. (Between 1993 and 2009, 132 cases of severe valproate hepatotoxicity were reported to the German Federal regulatory agency, of which 34 [25%] were fatal).
Chatzistefanidis D, Georgiou I, Kyritsis AP, Markoula S. (2012). Functional impact and prevalence of polymorphisms involved in the hepatic glucuronidation of valproic acid. Pharmacogenomics. (Review of the metabolism of valproate which is mainly via glucuronidation mediated by UDP glucuronsyltransferases [UGTs] in the liver).
van Zoelen MA, de Graaf M, van Dijk MR, Bogte A, van Erpecum KJ, Rockmann H, Maarschalk-Ellerbroek LJ. (2012). Valproic acid-induced DRESS syndrome with acute liver failure. Neth J Med. (26 year old man developed fever, rash, lymphadenopathy, facial edema and jaundice 6 weeks after starting valproate [bilirubin 10.9 mg/dL, ALT 2800 U/L, Alk P 456 U/L, protime 21.6 sec], eventually resolving after stopping and with corticosteroid therapy: Case 3).
Lin YH, Chien YL. (2012). Valproic acid-related anticonvulsant hypersensitivity syndrome and subsequent olanzapine-related neutropenia and thrombocytopenia: a case report. J Clin Psychopharmacol. (27 year old woman developed fever and rash 12 days after starting valproate [bilirubin and Alk P not given; ALT 107 U/L], resolving rapidly upon stopping and with prednisolone therapy, later developing neutropenia on olanzapine).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 2 of which were attributed to phenytoin, but none were linked to valproate use).
(2013). Drugs for epilepsy. Treat Guidel Med Lett. (Concise review of drugs of choice for epilepsy; valproate is effective in several forms of seizures and is also used to treat migraine headaches and bipolar disorder; serious adverse effects are uncommon, but fatal liver failure has been reported particularly in children but also in adults).
Rej S, Chen T, Edwards M, Zicherman V. (2014). Fulminant hepatic failure in the context of reinstituting valproate use. Psychosomatics. (61 year old woman with bipolar disorder restarted valproate [1000 mg daily] and developed fatigue, abdominal pain and delirium one month later [bilirubin 0.3 mg/dL, ALT >5000 U/L, Alk P not given, INR 1.9, glucose 79 mg/dL] with immediate improvement on stopping and normal liver tests within 1 week).
Star K, Edwards IR, Choonara I. (2014). Valproic acid and fatalities in children: a review of individual case safety reports in VigiBase. PLoS One. (Analysis of the WHO VigiBase registry of fatal drug adverse events in children reported between 1977 and 2012 identified 268 instances attributed to valproate, including 156 for hepatotoxicity mostly in children ages 6 and below but occurring at any age).
Chait Mermelstein A, Mermelstein J, Adam T, Brody BD, Dubin MJ. (2016). Oxcarbazepine-induced liver injury after sensitization by valproic acid: a case report. Bipolar Disord. (46 year old woman with bipolar disorder treated with valproate for 3 years was found to have abnormal liver enzymes elevations [ALT 163 U/L, Alk P 180 UL, bilirubin normal] which improved on stopping valproate, but ALT rose again when she was started on oxcarbazepine which resolved on stopping and recurred on restarting).
Mnif L, Sellami R, Masmoudi J. (2016). Valproic Acid and Hepatic Steatosis: A Possible Link? About a Case Report. Psychopharmacol Bull. (47 year old man with bipolar disorder on valproate developed abnormal liver tests [bilirubin normal, ALT 123 U/L] which rose further on continuation but resolved with switching to lithium; body mass index of 32 k/m2 and no data on weight change).
Gayam V, Khalid M, Shrestha B, Hossain MR, Dahal S, Garlapati P, Gill A, Mandal AK, Sangha R. (2018). Drug-induced liver injury: an institutional case series and review of literature. J Investig Med High Impact Case Rep. (Three cases of liver injury, case 3 being a 27 year old African-American man who developed liver injury 1 week after starting valproate [bilirubin 1.5 m/dL, ALT 7000 U/L, Alk P 96 U/L, INR 2.4, ammonia 184 µmol/L], resolving rapidly after stopping).
Gayam V, Mandal AK, Khalid M, Shrestha B, Garlapati P, Khalid M. (2018). Valproic acid induced acute liver injury resulting in hepatic encephalopathy- a case report and literature review. J Community Hosp Intern Med Perspect. (Same case as described above [Gayam 2018]).
Bassett JT, Rodriguez B, Mulligan L, Fontana RJ. (2019). Acute liver failure in a military recruit treated with valproic acid and harboring a previously unrecognized POLG-1 mutation. Epilepsy Behav Rep. (20 year old man with new onset seizure disorder developed fatigue followed by jaundice and change in mental status after starting valproate [bilirubin 4.5 mg/dL, ALT 283 U/L, INR 3.1], biopsy showing microvesicular fat and necrosis and with progressive course ultimately requiring liver transplantation, sequencing of POLG-1 showed p.A467T).
Walker CP, Deb S. (2019). Rhabdomyolysis and hepatotoxicity from valproic acid: case reports. J Pharm Pract. (Two patients with schizophrenia on long term valproate [5 and 7 years] and multiple other medications presented with acute severe rhabdomyolysis [bilirubin 1.1 and normal, ALT 22 and 54 U/L, CPK 15,368 and 21,980 U/L], with subsequent acute renal and hepatic failure, one fatal and one resolving after extensive intensive care management with continuation of valproate).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 7 [4%] of which were attributed to anticonvulsants including 3 due to valproate, one of which was fatal).
Devarbhavi H, Andrade RJ. (2014). Drug-induced liver injury due to antimicrobials, central nervous system agents, and nonsteroidal anti-inflammatory drugs. Semin Liver Dis. (Review of drug induced liver injury caused by several drug classes including antiepileptics, which account for 2-11% of all cases in various registries; a common presentation is with DRESS, particularly with the older agents such as carbamazepine, phenytoin and phenobarbital and often associated with reactivation of human herpes virus 6 or 7).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were due to anticonvulsants including 12 due to phenytoin, 9 lamotrigine, 7 valproate, 4 carbamazepine, 3 gabapentin, 2 topiramate and 1 each for ethosuximide, fosphenytoin, and pregabalin).
Chalasani N, Reddy KRK, Fontana RJ, Barnhart H, Gu J, Hayashi PH, Ahmad J, Stolz A, Navarro V, Hoofnagle JH. (2017). Idiosyncratic drug induced liver injury in African-Americans is associated with greater morbidity and mortality compared to Caucasians. Am J Gastroenterol. (Among subjects enrolled in a US prospective database of drug induced liver injury, causes more frequent in African Americans than Caucasian were trimethoprim/sulfamethoxazole, methyldopa, phenytoin and allopurinol, and African Americans were more likely to have severe skin adverse events [2.1% vs 0.4%], fatal or transplantation outcomes [10% vs 6%] as well as chronic injury [24% vs 16%]).
Vidaurre J, Gedela S, Yarosz S. (2017). Antiepileptic drugs and liver disease. Pediatr Neurol. (Review of the use of anticonvulsants in patients with liver disease recommends use of agents that have little hepatic metabolism such as levetiracetam, lacosamide, topiramate, gabapentin and pregabalin, levetiracetam being an "ideal" first line therapy for patients with liver disease because of its safety and lack of pharmacokinetic interactions).
(2017). Drugs for epilepsy. Med Lett Drugs Ther. (Concise review of the drugs available for therapy of epilepsy lists valproate as approved as monotherapy or adjunctive therapy for several forms of seizures and as generally well tolerated, common adverse effects being drowsiness, cognitive changes, nausea, weight gain, hyperinsulinemia, lipid abnormalities, and menstrual disturbances, and uncommon serious adverse events include fatal liver failure, particularly in children below the age of 2 years, hyperammonemia, pancreatitis, interstitial nephritis, parkinsonism and edema).
Borrelli EP, Lee EY, Descoteaux AM, Kogut SJ, Caffrey AR. (2018). Stevens-Johnson syndrome and toxic epidermal necrolysis with antiepileptic drugs: An analysis of the US Food and Drug Administration Adverse Event Reporting System. Epilepsia. (Review of adverse event reports to the FDA between 2014 and 2018 identified ~2.9 million reports, 1034 for SJS/TEN, the most common class of drugs implicated being anticonvulsants with 17 of 34 approved antiepileptics with at least one report, most frequent being lamotrigine [n=106], carbamazepine [22], levetiracetam [14], phenytoin [14], valproate [9], clonazepam [8] and zonisamide [7]; no mention of accompanying liver injury or whether attribution was as a single agent or one of several).
Haznedar P, Doğan Ö, Albayrak P, Öz Tunçer G, Teber S, Deda G, Eminoglu FT. (2019). Effects of levetiracetam and valproic acid treatment on liver function tests, plasma free carnitine and lipid peroxidation in childhood epilepsies. Epilepsy Res. (In a cross sectional analysis of 51 children with epilepsy treated with valproate or levetiracetam, serum ALT, AST and GGT levels were in the normal range in all and did not differ from a group of healthy controls).
Cano-Paniagua A, Amariles P, Angulo N, Restrepo-Garay M. (2019). Epidemiology of drug-induced liver injury in a University Hospital from Colombia: Updated RUCAM being used for prospective causality assessment. Ann Hepatol. (Among 286 patients with liver test abnormalities seen in a single hospital in Colombia over a 1 year period, 17 were diagnosed with drug induced liver injury, the most common cause being antituberculosis therapy [n=6] followed by anticonvulsants [n=3, 1 each due to phenytoin, gabapentin and valproate]).
Kapur J, Elm J, Chamberlain JM, Barsan W, Cloyd J, Lowenstein D, Shinnar S, et al., NETT and PECARN Investigators. (2019). Randomized trial of three anticonvulsant medications for status epilepticus. N Engl J Med. (Among 384 adults and children with status epilepticus not responding to benzodiazepines who were treated with intravenous levetiracetam, fosphenytoin or valproate, seizure control at 60 minutes was similar in all 3 groups [47%, 45%, and 46%], and adverse event rates were similar while hepatic failure occurred in one patient on fosphenytoin and abnormal liver tests were reported in one patient on valproate).
Chamberlain JM, Kapur J, Shinnar S, Elm J, Holsti M, Babcock L, Rogers A, et al. (2020). Neurological Emergencies Treatment Trials; Pediatric Emergency Care Applied Research Network investigators. Efficacy of levetiracetam, fosphenytoin, and valproate for established status epilepticus by age group (ESETT): a double-blind, responsive-adaptive, randomised controlled trial. Lancet. (An extension of the trial reported by Kapur [2019] allowed for analysis of response rates by age group, control of seizures was similar with the three agents across all age groups and adverse event rates were also similar).
Sridharan K, Daylami AA, Ajjawi R, Ajooz HAMA. (2020). Drug-induced liver injury in critically ill children taking antiepileptic drugs: a retrospective study. Curr Ther Res Clin Exp. (Among 41 children admitted to a pediatric intensive care unit who received anticonvulsants for seizure control, 5 of 9 receiving phenobarbital alone, 9 of 12 receiving phenytoin alone but none of six receiving valproate developed liver test abnormalities [all hepatocellular], the timing, height and outcome of which were not given).
Vignesh V, Rameshkumar R, Mahadevan S. (2020). Comparison of phenytoin, valproate and levetiracetam in pediatric convulsive status epilepticus: a randomized double-blind controlled clinical trial. Indian Pediatr. (Among 110 children with status epilepticus not responding to intravenous benzodiazepines who were treated with intravenous infusions of phenytoin, valproate or levetiracetam, the rate of seizure control was similar in the 3 groups and adverse events were rare; no mention of liver injury or ALT elevations).

## OTHER REFERENCE LINKS

1 Recent References on Valproate: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(valproate/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Valproate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=valproate)